# Spirulina

## OVERVIEW

### Introduction

Spirulina is a dietary supplement made from blue-green algae (cyanobacteria: Arthrospira platensis) that is used both as a food and as a medicinal supplement to counteract unintentional weight loss and to ameliorate a variety of medical conditions including attention-deficit hyperactivity disorder, allergic rhinitis, hypertension, diabetes, stress, fatigue, anxiety and depression. Spirulina has been implicated in isolated case reports in causing clinically apparent liver injury, but the role of spirulina as opposed to other herbal components or contaminants has not been shown. Liver injury due to spirulina must be very rare if it occurs at all.

### Background

Spirulina is a dietary supplement prepared from the biomass of blue-green algae which is rich in protein, vitamins and minerals. Spirulina refers to a large number of photosynthetic eubacterial species belonging to the phylum Cyanobacteria (Arthrospira platensis and maxima). While known as blue-green algae, spirulina it is a prokaryotic, eubacterial species belonging to the phylum Cyanobacteria. Spirulina typically grows in warm open lakes with high alkalinity and can be contaminated with other blue-green algae that produce toxins (microcystins). Spirulina has been used as a food and source of nutrients for centuries by the people of Mexico and Central America but only recently has been prepared as commercial dietary supplements. Spirulina is particularly rich in protein (65% to 70%) as well as vitamins, phycocyanin, beta-carotene, polyunsaturated fatty acids, linolenic acid, calcium and iron. The blue-green pigment phycocyanin accounts for up to 20% of its dry weight and has been proposed to be the active ingredient responsible for its medicinal properties. In animal experiments, spirulina has demonstrated antioxidant, antiinflammatory and analgesic effects and has been well tolerated without evidence of toxicity even in high doses. There have been limited studies in humans, but it has not been proven to be effective in treating any medical condition. Studies have found it to be safe without significant adverse events.

### Hepatotoxicity

In controlled trials, spirulina has not been linked to serum enzyme elevations or to instances of clinically apparent liver injury. Indeed, in several studies serum aminotransferase levels have decreased with spirulina therapy, and it has been evaluated in uncontrolled studies as a potential therapy of nonalcoholic steatohepatitis. Despite its long history of use and safety, spirulina has recently been implicated in at least published case of clinically apparent liver injury and in several reports of hepatic injury to national registries of adverse drug events. In the single case report, the latency to onset of jaundice was 5 weeks and the injury was hepatocellular, without immunoallergic or autoimmune features and with rapid and complete recovery on withdrawal. The patient was also taking several other drugs that can cause liver injury which were stopped at the same time including acarbose and simvastatin. Thus, spirulina may cause clinically apparent liver injury, but it is quite rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which spirulina might cause liver injury is unclear. Contamination of the product with other cyanobacteria with cytotoxic microcystins is a possible explanation. The concentration, purity and freedom from contaminants from the commercial preparations of spirulina implicated in liver injury have not been reported.

### Outcome and Management

The severity of the liver injury in reports of spirulina hepatotoxicity has varied from mild, asymptomatic elevations in serum enzymes to self-limiting, clinically apparent hepatitis. There have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to spirulina. There is no information on management or the role for corticosteroids or other interventions except for prompt discontinuation of the suspected agent.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Spirulina – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/923.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Spirulina | S058500000 (https://chem.sis.nlm.nih.gov/chemidplus/direct.jsp?regno=S058500000) | Extract | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations used: HDS, herbal and dietary supplements

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; spirulina is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbs and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of HDS; spirulina is not discussed).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; spirulina is not listed as causing hepatotoxicity).
Iwasa M, Yamamoto M, Tanaka Y, Kaito M, Adachi Y. (2002). Spirulina-associated hepatotoxicity. Am J Gastroenterol. (52 year old Japanese man with hypertension and diabetes developed liver test abnormalities 2 weeks after starting spirulina [ALT 136 U/L] which worsened on continuing [bilirubin 2.2 mg/dL, ALT 1726 U/L, Alk P 281 U/L, GGT 301 U/L], resolving within 6 weeks of stopping spirulina as well as his other medications including simvastatin, amlodipine and acarbose).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were attributed to spirulina).
Ferreira-Hermosillo A, Torres-Duran PV, Juarez-Oropeza MA. (2010). Hepatoprotective effects of Spirulina maxima in patients with non-alcoholic fatty liver disease: a case series. J Med Case Rep. (Three patients with nonalcoholic fatty liver disease were treated with spirulina [4.5 g daily] and had improvements in serum ALT, triglyceride and LDL-cholesterol levels without adverse side effects).
Deng R, Chow TJ. (2010). Hypolipidemic, antioxidant, and antiinflammatory activities of microalgae Spirulina. Cardiovasc Ther. (Review of the preclinical studies of spirulina suggesting hypolipidemic, antioxidant and antiinflammatory activity and the few clinical studies concludes that despite isolated reports of toxicity, “Spirulina is generally considered safe for human consumption supported by its long history of use as food source, and its favorable safety profile in animal studies”).
Marles RJ, Barrett ML, Barnes J, Chavez ML, Gardiner P, Ko R, Mahady GB, et al. (2011). United States pharmacopeia safety evaluation of spirulina. Crit Rev Food Sci Nutr. (Formal systematic analysis of the safety of spirulina by the US Pharmacopeia based upon the published literature as well as FDA and other national adverse event registries identified multiple reports of possible liver injury; one published [Iwasa 2002], 5 from the FDA’s MedWatch and 3 from a Canadian registry, but none from Australia, the UK or Europe; because the reports had inadequate detail to exclude competing diagnoses and possible contaminants, the USP concluded that spirulina should be considered safe, but that prospective studies of its safety were warranted).
Karkos PD, Leong SC, Karkos CD, Sivaji N, Assimakopoulos DA. (2011). Spirulina in clinical practice: evidence-based human applications. Evid Based Complement Alternat Med. (Review of the potential clinical benefits of spirulina concludes that “what the literature suggests is that Spirulina is a safe food supplement without significant side effects but its role as a drug remains to be seen”).
Yakoot M, Salem A. (2012). Spirulina platensis versus silymarin in the treatment of chronic hepatitis C virus infection. A pilot randomized, comparative clinical trial. BMC Gastroenterol. (Among 66 patients with chronic hepatitis C treated with spirulina or silymarin for 6 months, serum ALT levels decreased more with spirulina [-24 vs –7 U/L] and serum HCV RNA levels decreased in some patients, and there were no serious adverse events).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements; does not list spirulina).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention spirulina).
Mazokopakis EE, Papadomanolaki MG, Fousteris AA, Kotsiris DA, Lampadakis IM, Ganotakis ES. (2014). The hepatoprotective and hypolipidemic effects of Spirulina (Arthrospira platensis) supplementation in a Cretan population with non-alcoholic fatty liver disease: a prospective pilot study. Ann Gastroenterol. (Among 15 men from Crete with nonalcoholic fatty liver disease treated with spirulina [6 g daily] for 6 months, mean ALT levels decreased [104 to 65 U/L] as did AST [66 to 41 U/L], cholesterol [275 to 250 mg/dL] and body weight [103 to 95 kg], and no patient reported any side effects).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to spirulina).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products does not mention or discuss spirulina).
Jensen GS, Drapeau C, Lenninger M, Benson KF. (2016). Clinical safety of a high dose of phycocyanin-enriched aqueous extract from Arthrospira (Spirulina) platensis: results from a randomized, double-blind, placebo-controlled study with a focus on anticoagulant activity and platelet activation. J Med Food. (Among 24 adults with chronic joint pain treated with high doses of an aqueous spirulina extract or placebo for 2 weeks, pain scores and serum ALT and AST levels improved with the extract vs placebo, while other laboratory values, platelet numbers and coagulation measurements did not change).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention or discuss spirulina).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products; does not mention spirulina).
Zeinalian R, Farhangi MA, Shariat A, Saghafi-Asl M. (2017). The effects of Spirulina Platensis on anthropometric indices, appetite, lipid profile and serum vascular endothelial growth factor (VEGF) in obese individuals: a randomized double blinded placebo-controlled trial. BMC Complement Altern Med. (Among 64 obese adults treated with spirulina [500 mg] or placebo twice daily for 12 weeks, weight decreased slightly more with spirulina [-1.6 vs -0.6 kg] while change in serum lipids did not differ in the two groups, and “no side effects of treatment were observed”).
Finamore A, Palmery M, Bensehaila S, Peluso I. (2017). Antioxidant, immunomodulating, and microbial-modulating activities of the sustainable and ecofriendly spirulina. Oxid Med Cell Longev. (Review of the preclinical and clinical evidence for antioxidant, antiinflammatory and immunomodulatory effects of spirulina, mentions that that expert committees have concluded that it is generally safe and is not a serious risk to health).

## OTHER REFERENCE LINKS

1 Recent References on Spirulina: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Spirulina/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Spirulina: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Spirulina)